# Capecitabine

## OVERVIEW

### Introduction

Capecitabine is a pyrimidine analogue used as an antineoplastic agent to treat metastatic and advanced forms of breast and colon cancer, often in combination with other agents. Capecitabine is associated with a low rate of transient serum aminotransferase elevations during therapy but has been only rarely implicated in cases of clinically apparent acute liver injury.

### Background

Capecitabine (kap" e sye' ta been) is a pyrimidine analogue (pentyloxycarbonyl-deoxy-fluorocytidine) that has antineoplastic action against several solid tumors, including breast and colon cancers. Capecitabine is a prodrug of 5-fluorouracil (5-FU) and is converted to this active metabolite intracellularly, where it acts by interfering with DNA, RNA and protein synthesis and inhibiting cell division. Unlike 5-FU, capecitabine can be given by mouth. Furthermore, capecitabine is converted to 5-FU in a three step process, the first of which takes place in the liver and the last two predominantly in tumor cells, which may account for why it is better tolerated than 5-FU. Capecitabine was approved for use as an anticancer agent in the United States in 1998 and is currently an important component of several cancer chemotherapeutic regimens. Current indications include advanced, metastatic breast cancer and colorectal cancers, usually after failure of first line therapies. Capecitabine is available as tablets of 150 and 500 mg generically and under the brand name Xeloda. The recommended dose is based upon body surface area and renal function, but is generally initiated in a dose of 2.5 grams per meter squared in two divided doses daily for 2 weeks, followed by a 1 week rest period and then repeated at irregular intervals in 3 week cycles. Common side effects include bone marrow suppression, diarrhea, nausea, vomiting, hand-foot syndrome, fatigue, weakness, headache, dizziness, insomnia, paresthesias, abdominal pain, stomatitis, and rash.

### Hepatotoxicity

Serum aminotransferase elevations occur in a proportion of patients on conventional doses of capecitabine therapy, but elevations above 5 times the upper limit of normal are uncommon, occurring in <1% of patients. Mild serum bilirubin elevations are also common during capecitabine therapy, occurring in up to 40% of patients. The bilirubin elevations, however, are largely in the indirect (unconjugated) fraction and are usually isolated (without other liver test abnormalities), self-limited and mild. There have been no individual published case reports of clinically apparent liver injury attributed to capecitabine, but single instances of cholestatic hepatitis have been reported in clinical trials and are mentioned in the product label. The clinical features of the liver injury, such as the latency to onset, pattern of serum enzyme elevations, presence of immunoallergic or autoimmune features and typical course and outcome have not been well defined. In some reports, the serum enzyme elevations were accompanied by steatosis and inflammation which resolved when chemotherapy was discontinued.

Likelihood score: E* (Unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

While hepatotoxicity from capecitabine may be rare, it is likely due to direct hepatotoxicity. Capecitabine is extensively metabolized in the liver via the microsomal enzyme system (predominantly 2C9), and production of a toxic or immunogenic intermediate may trigger liver injury. Capecitabine is susceptible to drug-drug interactions with anticoagulants and anticonvulsants.

### Outcome and Management

The severity of the liver injury linked to capecitabine therapy is generally mild. Capecitabine has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between capecitabine and 5-FU or other pyrimidine analogues.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Pyrimidine Analogues: Azacitidine, Cytarabine, Decitabine, Floxuridine, Fluorouracil, Gemcitabine, Trifluridine/Tipracil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Capecitabine – Generic, Xeloda®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Capecitabine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Capecitabine | 154361-50-9 | C15-H22-F-N3-O6 | Capecitabine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2017

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; capecitabine is not discussed).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam, Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Capecitabine. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, p. 1698. (Textbook of pharmacology and therapeutics; capecitabine is a fluoropyrimidine analogue that is used in advanced and metastatic breast and colon cancer).
Van Cutsem E, Twelves C, Cassidy J, Allman D, Bajetta E, Boyer M, Bugat R, et al.; Xeloda Colorectal Cancer Study Group. Oral capecitabine compared with intravenous fluorouracil plus leucovorin in patients with metastatic colorectal cancer: results of a large phase III study. J Clin Oncol 2001; 19: 4097-106. (Among 602 patients randomized to capecitabine vs 5-FU with leucovorin, serum ALT elevations occurred in 0.7% vs 1.0% and bilirubin elevations in 28.3% vs 6.3%). 11689577
Cassidy J, Twelves C, Van Cutsem E, Hoff P, Bajetta E, Boyer M, Bugat R, et al.; Capecitabine Colorectal Cancer Study Group. First-line oral capecitabine therapy in metastatic colorectal cancer: a favorable safety profile compared with intravenous 5-fluorouracil/leucovorin. Ann Oncol 2002; 13: 566-75. (Analysis of results from 1207 patients enrolled in controlled trial of oral capecitabine vs intravenous 5-FU with leucovorin; efficacy was similar, but capecitabine was better tolerated with less diarrhea, stomatitis, nausea and neutropenia but more hand-foot syndrome; ALT elevations >5 times ULN occurred in 0.5% vs 0.7%, but bilirubin elevations >1.5 times ULN were more common with capecitabine [26.3%] than 5-FU [8.4%], elevations being isolated and self-limited; "hepatobiliary abnormalities" resulted in discontinuation in 2 patients on capecitabine and 4 on 5-FU). 12056707
Walko CM, Lindley C. Capecitabine: a review. Clin Ther 2005; 27: 23-44. (Review of the development of capecitabine, its mechanism of action, efficacy and safety in various solid tumors; major side effects are anemia, diarrhea, hand-foot syndrome and nausea; hyperbilirubinemia occurs in 40% of patients, but is usually mild and self-limited; no discussion of hepatotoxicity). 15763604
Blum JL, Jones SE, Buzdar AU, LoRusso PM, Kuter I, Vogel C, Osterwalder B, et al. Multicenter phase II study of capecitabine in paclitaxel-refractory metastatic breast cancer. J Clin Oncol 1999; 17: 485-93. (Among 162 patients with advanced breast cancer treated with 3 week cycles of capecitabine [twice daily for 2 weeks followed by a week rest], common side effects were hand-foot syndrome, diarrhea, nausea and fatigue; ALT elevations above 5 times ULN occurred in only 1 patient [<1%]). 10080589
Mikhail SE, Sun JF, Marshall JL. Safety of capecitabine: a review. Expert Opin Drug Saf 2010; 9: 831-41. (Review of structure, mechanism of action, pharmacology, efficacy and safety of capecitabine, an oral prodrug of 5-FU; ALT elevations above 5 times the ULN occurred in <1% of patients in most studies, but in as many as 38% of patients in trials using higher doses). 20722491
Chin SN, Kim TK, Siu LL. Hepatic steatosis secondary to capecitabine: a case report. J Med Case Rep 2010; 4: 227. (74 year old woman with colon cancer and diabetes developed asymptomatic ALT elevations after 3 cycles of capecitabine [ALT rising from 7 to 57-101 U/L, bilirubin rising from 0.4 to 1.0-1.4 mg/dL, Alk P not provided] with MRI findings suggestive of fatty liver, and resolution with stopping capecitabine and not recurring with a subsequent cycle). 24576340
Oostendorp LJ, Stalmeier PF, Donders AR, van der Graaf WT, Ottevanger PB. Efficacy and safety of palliative chemotherapy for patients with advanced breast cancer pretreated with anthracyclines and taxanes: a systematic review. Lancet Oncol 2011; 12: 1053-61. (Pooled analysis of 1404 patients enrolled in 10 trials of capecitabine monotherapy for advanced breast cancer; diarrhea occurred in 0-19% and hand-foot syndrome in 2-24%; no mention of liver injury or ALT elevations). 21621462
Blum JL, Barrios CH, Feldman N, Verma S, McKenna EF, Lee LF, Scotto N, et al. Pooled analysis of individual patient data from capecitabine monotherapy clinical trials in locally advanced or metastatic breast cancer. Breast Cancer Res Treat 2012; 136: 777-88. (Among 805 patients treated with capecitabine in 7 clinical trials, 54% reported at least one adverse event which led to stopping therapy in 38 [7%] and death in 2 [<1%], but none of the severe events were liver related and ALT elevations were not reported). 23104222
O'Shaughnessy JA, Kaufmann M, Siedentopf F, Dalivoust P, Debled M, Robert NJ, Harbeck N. Capecitabine monotherapy: review of studies in first-line HER-2-negative metastatic breast cancer. Oncologist 2012; 17: 476-84. (Review of capecitabine as a potential first line drug for metastatic breast cancer that is HER-2 negative; no discussion of hepatotoxicity or ALT elevations). 22418569
Kadoyama K, Miki I, Tamura T, Brown JB, Sakaeda T, Okuno Y. Adverse event profiles of 5-fluorouracil and capecitabine: data mining of the public version of the FDA Adverse Event Reporting System, AERS, and reproducibility of clinical observations. Int J Med Sci 2012; 9: 33-9. (Among 34,948 spontaneous adverse event reports on capecitabine, common events were diarrhea [1790], nausea [842], head-foot syndrome [456] and fatigue [386]; liver injury was not in the list of the top 20 adverse events). 22211087
Gurzu S, Jung I, Comsulea M, Kadar Z, Azamfirei L, Molnar C. Lethal cardiotoxicity, steatohepatitis, chronic pancreatitis, and acute enteritis induced by capecitabine and oxaliplatin in a 36-year-old woman. Diagn Pathol 2013; 8: 150. (36 year old woman developed severe abdominal pain and multiorgan failure 1 month after finishing 5 courses of capecitabine and oxaliplatin for pancreatic cancer [bilirubin 6.3 mg/dL, ALT 40 U/L Alk P not given, platelets 114,000/µL] and on autopsy had ascites and marked steatohepatitis with moderate fibrosis only, suggestive of nodular regenerative hyperplasia). 24041405
Zhu LQ, Jiang WT, Pan C, Liu YH, Thian Y. Liver injury possibly related to drug interaction after liver transplant: a case report. J Clin Pharm Ther 2014; 39: 439-41. (29 year old man developed liver injury 2 months after liver transplantation for HBV related liver cancer and while receiving capecitabine and warfarin for uncertain reasons [ALT 909 U/L, Alk P and bilirubin not provided], with progressive injury resulting in death despite stopping both agents; no autopsy or tissue diagnosis made). 24661191
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective database between 2004 and 2013, 49 [5.5%] were due to antineoplastic agents, but none were attributed specifically to capecitabine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Capecitabine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Capecitabine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Capecitabine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Capecitabine)